# Passionflower

## OVERVIEW

### Introduction

Passionflower is an extract of the flowers of the plant Passiflora incarnata that is claimed to have natural sedative properties and to be useful for treatment of anxiety and insomnia. Passionflower has not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

Passionflower is a flowering plant, extracts of which have been used as a mild sedative and sleeping aid. The genus Passiflora includes more than 500 species which typically have complex and unique structures and flowers, and are found throughout much of the world. Passiflora incarnata (maypop) is indigenous to the United States and Central and South America and was used by Native Americans to treat insomnia, hysteria, epilepsy and as a mild analgesic. Other species of Passiflora reportedly lack these medicinal effects. Passionflower contains several flavonoids (apigenin, benzoflavone and others), harmala alkaloids (hamaline, harmalol, harmine and harmol), coumarins, maltol, phytosterols and glycosides. Studies in animals suggest that extracts of passionflower have sedative, anxiolytic, analgesic and antispasmodic effects but the specific components responsible for these effects have not been defined. The herb is used most frequently as a mild sleeping medication, sedative, and treatment for gastrointestinal complaints often in the form of an herbal tea, but also in multiple herbal preparations, generally in combination with other agents including valerian, hops and lavender. Passionflower is also used in creams, lotions, soaps and cosmetics. Side effects of oral use are not common but can include dizziness, sedation, confusion and ataxia.

### Hepatotoxicity

Despite widescale use, passionflower extracts have not been convincingly linked to instances of clinically apparent liver injury. However, there have been no placebo controlled and adequate sized trials with careful prospective assessment of adverse events and effects on laboratory test results.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Apricot vine, Granadilla, Maypop, Passion vine

Drug Class: Herbal and Dietary Supplements

See also Drug Class: Sedatives and Hypnotics

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Passionflower – Generic (OTC Products)

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health (https://nccih.nih.gov/health/passionflower)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=PASSION+FLOWER&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Passionflower Extract | 8057-62-3 | Unspecified | No Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 28 March 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbals are discussed, including comfrey, Jin Bu Huan, germander, chaparral leaf, skullcap and valerian, but not passionflower).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS]; passionflower is not discussed).
Passion flower. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 634-5. (Compilation of short monographs on herbal medications and dietary supplements).
Gyllenhaal C, Merritt SL, Peterson SD, Block KI, Gochenour T. (2000). Efficacy and safety of herbal stimulants and sedatives in sleep disorders. Sleep Med Rev. (Review of herbals used for sleep disorders; mentions that animal studies suggest that passionflower has sedative effects, but there has been little clinical study of their efficacy in humans).
Wheatley D. (2005). Medicinal plants for insomnia: a review of their pharmacology, efficacy and tolerability. J Psychopharmacol. (Review of herbals used to treat insomnia; mentions that there appears to be a complete lack of clinical research on passionflower).
Meolie AL, Rosen C, Kristo D, Kohrman M, Gooneratne N, Aguillard RN, Fayle R, et al., Clinical Practice Review Committee. (2005). American Academy of Sleep Medicine. Oral nonprescription treatment for insomnia: an evaluation of products with limited evidence. J Clin Sleep Med. (Systematic review of efficacy of nonprescription treatments for insomnia states that there is scientific evidence that passionflower has hypnotic efficacy and adverse effects including dizziness, confusion, and ataxia).
Ngan A, Conduit R. (2011). A double-blind, placebo-controlled investigation of the effects of Passiflora incarnata (passionflower) herbal tea on subjective sleep quality. Phytother Res. (Crossover trial of 1 week course of passionflower vs placebo tea in 41 subjects found short term subjective improvement in sleep quality with the herbal tea; side effects were not mentioned).
Sarris J, Panossian A, Schweitzer I, Stough C, Scholey A. (2011). Herbal medicine for depression, anxiety and insomnia: a review of psychopharmacology and clinical evidence. Eur Neuropsychopharmacol. (Overview and summary of herbals used to treat anxiety, depression and insomnia; ranks passionflower and valerian as having evidence level "C" for efficacy in insomnia in humans; no mention of adverse events).
(2012). Drugs for insomnia. Treat Guidel Med Lett. (Guidelines for therapy of insomnia; mentions herbal products that are claimed to have sleep inducing effects including valerian root, kava, chamomile tea, passionflower, hops, lemon balm, lavender and skull cap, but that there is no convincing evidence for their efficacy and that the purity of commercially available, over-the-counter products is suspect).
Miroddi M, Calapai G, Navarra M, Minciullo PL, Gangemi S. (2013). Passiflora incarnata L.: ethnopharmacology, clinical application, safety and evaluation of clinical trials. J Ethnopharmacol. (Extensive and careful review of the history, chemistry, pharmacology, preclinical evaluation and clinical trials of passionflower concludes that its “supposed efficacy does not appear to be adequately corroborated by the literature”, but that it has a “good safety profile”, the shortcomings being small numbers of subjects and short durations of therapy, lack of placebo controls, and use of commercial combinations without documentation of purity or concentrations; no mention of effects on ALT levels or hepatotoxicity).
Maroo N, Hazra A, Das T. (2013). Efficacy and safety of a polyherbal sedative-hypnotic formulation NSF-3 in primary insomnia in comparison to zolpidem: a randomized controlled trial. Indian J Pharmacol. (Among 91 adults with insomnia treated with a fixed combination of valerian [300 mg], passionflower [80 mg] and hops [30 mg] or zopidem at bedtime for 2 weeks, sleep time and insomnia index improved similarly in both groups and there were no serious adverse events and “none of the laboratory parameters changed significantly from baseline” which included tests of “hepatorenal function”).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, passion flower was not implicated in any of the cases).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products, but does not list any attributed to passion flower).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, passion flower is not listed or mentioned).
de Boer YS, Sherker AH. (2017). Herbal and dietary supplement-induced liver injury. Clin Liver Dis. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, kava, pyrrolizidine alkaloids and proprietary multiingredient dietary supplements [MIDS]; does not mention passion flower).
Mansoor K, Qadan F, Hinum A, Schneider C, Hechenbichler K, Schmidt M, Linsinger G, Matalka K. (2018). An open prospective pilot study of a herbal combination "Relief" as a supportive dietetic measure during alcohol withdrawal. Neuro Endocrinol Lett. (Among 32 patients hospitalized for alcohol withdrawal treated for 15 days with “Relief” a fixed combination of extracts of saffron, passionflower, cocoa sed, radish and cumin, withdrawal symptoms improved and adverse events were mild, serum ALT, AST and GGT improving by 50% overall, but there was no comparison to placebo or standard of care therapy).
Lemoine P, Bablon JC, Da Silva C. (2019). A combination of melatonin, vitamin B6 and medicinal plants in the treatment of mild-to-moderate insomnia: A prospective pilot study. Complement Ther Med. (Among 40 adults with insomnia treated with a fixed combination of melatonin, vitamin B6, and extracts of California poppy, lemon balm and passion flower for 2 weeks reported that it improved sleep quality and was well tolerated with no serious adverse events or discontinuations).

## OTHER REFERENCE LINKS

1 Recent References on Passionflower: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Passionflower/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Passionflower: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Passionflower)